# Relugolix

## OVERVIEW

### Introduction

Relugolix is an orally administered, small molecule antagonist of gonadotropin releasing hormone (GnRH) that effectively blocks androgen production and is used to treat advanced prostate cancer. Relugolix therapy may be associated with a low rate of serum enzyme elevations during therapy, but has yet to be linked to instances of clinically apparent acute liver injury.

### Background

Relugolix (rel’ ue goe” lix) is a small molecule, non-peptide antagonist of gonadotropin releasing hormone (GnRH) that blocks GnRH stimulation of luteinizing hormone (LH) and follicular stimulating hormone (FSH) production by the pituitary gland, thereby decreasing the synthesis of testosterone by the testes in men and estrogen by the ovaries in women. Relugolix has been found to be palliative in advanced prostate cancer with equivalent efficacy to the parenterally administered GnRH peptide analogues, such as leuprolide and degarelix. Because relugolix is an antagonist of GnRH, it does not cause the initial increase in testosterone synthesis that occurs with use of GnRH agonists and generally has a more rapid onset of action. Relugolix was approved for use in the United States in 2020, and current indications are limited to therapy of advanced prostate cancer. GnRH analogues have also been used off label for precocious puberty, infertility, and as a part of gender affirming therapy. Relugolix is available under the brand name Orgovyk as tablets of 120 mg. It is typically initiated with a loading dose of 360 mg (3 tablets) followed by 120 mg daily. Common side effects include symptoms of hypogonadism such as hot flashes, decreased libido, hair thinning or loss, erectile dysfunction, nausea, diarrhea, weight gain and fluid retention. Rare but potentially severe adverse reactions include QT/QTc prolongation, hypersensitivity reactions [including angioedema] and embryo-fetal toxicity.

Relugolix in fixed combination with estradiol (an estrogen) and norethindrone acetate (a progestin) has been evaluated as therapy of endometriosis and uterine fibroids and was approved in the United States for therapy of heavy menstrual bleeding associated with leiomyomas (fibroids) in premenopausal women in 2021. Indications were broadened to include pain from uterine fibroids in 2022. This combination is available under the brand name Myfembree. Each tablet contains 40 mg of relugolix, 1 mg of estradiol (E2) and 0.5 mg of norethindrone acetate (NA), the latter two agents being the constituents of a previously FDA approved therapy for menopausal symptoms and are added to lessen the symptoms of estrogen deprivation and bone loss. In registration trials, the relugolix/E2/NA combination was associated with a marked decrease in menstrual bleeding and decreased in pain associated with uterine fibroids, and was generally well tolerated with few of the typical adverse events caused by GnRH antagonist induced hypogonadism.

### Hepatotoxicity

Relugolix therapy has been associated with serum aminotransferase elevations above 3 times the upper limit of normal (ULN) in 1% to 3% of patients and in similar proportions of patients receiving comparator agents such as leuprolide or degarelix. The serum enzyme elevations are generally mild and self-limited, resolving even without dose adjustment. ALT values above 5 times the ULN occur in less than 1% of patients, and episodes of ALT elevations with symptoms or jaundice were not observed in preregistration clinical trials of relugolix alone or in combination with estradiol and norethindrone. Since its approval and more widescale use, there have been no published reports of clinically apparent liver injury attributed to relugolix.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which relugolix might cause liver injury is unknown. It is a synthetic small molecule that is metabolized in the liver by the cytochrome P450 system (predominantly CYP 3A4] and is a substrate for P glycoprotein. Strong inhibitors of CYP 3A4 and P glycoprotein can increase serum levels and the risk of toxicity, while inducers can result in suboptimal drug levels.

### Outcome and Management

The serum aminotransferase elevations that arise in 1% to 3% of patients during relugolix therapy are generally transient, mild, and not accompanied by symptoms or jaundice, and the elevations rarely require dose adjustment or drug discontinuation. Routine monitoring of liver tests is not recommended except in patients with known, preexisting liver disease. There is no evidence of cross sensitivity to liver injury among the various GnRH analogues.

Drug Class: Antineoplastic Agents, GnRH Analogues

Other Drugs in the Subclass, GnRH Analogues: Degarelix, Goserelin, Histrelin, Leuprolide, Triptorelin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Relugolix – Orgovyk®, Myfembree®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Relugolix)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Relugolix | 737789-87-6 | C29-H27-F2-N7-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 28 May 2023

Abbreviations: FSH, follicle stimulating hormone; GnRH, gonadotropin releasing hormone; LH, luteinizing hormone; PSA, prostate specific antigen.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999; the GnRH antagonists such as leuprolide and relugolix are not discussed).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of hormonal products, does not discuss the GnRH analogues such as leuprolide, goserelin, degarelix, and relugolix).
Levin ER, Vitek WS, Hammes SR. Estrogens, progestins, and the female reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 803-31. (Textbook of pharmacology and therapeutics).
Snyder PJ. Androgens and the male reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 833-43. (Textbook of pharmacology and therapeutics).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-47. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/214621Orig1s000MultidisciplineR.pdf (FDA website with the multidisciplinary review of the application for approval with data and analysis of its safety and efficacy, mentions that in the large registration trial of 930 patients with advanced prostate cancer, there were no hepatic deaths or serious hepatic adverse events, and serum aminotransferase elevations above 3 times ULN arose in 9 of 622 [1.4%] patients receiving relugolix vs 4 of 308 [1.3%] receiving leuprolide, none of whom developed clinical symptoms or jaundice or required drug discontinuation for the hepatic enzyme elevations).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to GnRH analogues such as goserelin, leuprolide, histrelin, or degarelix).
Markham A. Relugolix: first global approval. drugs. 2019;79:675-679. (Review of the structure, mechanism of action, history of development, pharmacology, clinical efficacy, and safety of relugolix shortly after its approval in Japan as therapy of uterine fibroids, mentions that serum aminotransferase elevations arose in 2.2% of patients on relugolix vs 1.4% on leuprolide).
Dearnaley DP, Saltzstein DR, Sylvester JE, Karsh L, Mehlhaff BA, Pieczonka C, Bailen JL, et al. (2020). The oral gonadotropin-releasing hormone receptor antagonist relugolix as neoadjuvant/adjuvant androgen deprivation therapy to external beam radiotherapy in patients with localised intermediate-risk prostate cancer: a randomised, open-label, parallel-group phase 2 trial. Eur Urol. (Among 103 men with prostate cancer receiving radiotherapy who were treated with androgen deprivation therapy with relugolix [120 mg tablets daily] or degarelix [80 mg injections monthly], suppression of testosterone and PSA levels were similar in the two groups and adverse events were slightly fewer with relugolix [86% vs 97%], ALT elevations arising in none vs 13% but none were greater than 5 times ULN).
Shore ND, Saad F, Cookson MS, George DJ, Saltzstein DR, Tutrone R, Akaza H, et al., HERO Study Investigators. (2020). Oral relugolix for androgen-deprivation therapy in advanced prostate cancer. N Engl J Med. (Among 930 men with advanced prostate cancer treated with relugolix [120 mg daily by mouth] or leuprolide [by injection every 3 months] for 48 weeks, sustained suppression of testosterone to castration levels was achieved by 97% on relugolix vs 89% on leuprolide, while common adverse event rates were similar with ALT elevations above 3 times ULN in 1.4% vs 1.3%, although major adverse cardiovascular events arose in 2.8% vs 5.6%).
Sawazaki H, Kitamura Y, Yagi K, Arai Y. (2020). Impact of androgen deprivation therapy on non-alcoholic fatty liver disease in patients with prostate cancer: a CT evaluation. Urol Int. (Among 77 patients with prostate cancer treated with androgen deprivation therapy [32 with leuprolide and 45 degarelix] for 6 months, computerized tomography demonstrated development of fatty liver in 7 patients but little change in body weight).
Al-Hendy A, Lukes AS, Poindexter AN, Venturella R, Villarroel C, Critchley HOD, Li Y, McKain L, et al. (2021). Treatment of uterine fibroid symptoms with relugolix combination therapy. N Engl J Med. (Among 770 women with uterine fibroids and heavy menstrual bleeding enrolled in two prospective clinical trials comparing the combination of relugolix [120 mg] with estrogen and progesterone vs placebo once daily for 24 weeks vs relugolix alone for 12 weeks followed by [delayed] combination therapy for 12 weeks [delayed], response rates were higher with combination relugolix [71% to 80% vs 15% and 17%] and monotherapy was associated with a decrease in bone mineral density and more frequent hot flashes; ALT elevations above 3 times ULN arose in less than 1% of all groups).
Osuga Y, Seki Y, Tanimoto M, Kusumoto T, Kudou K, Terakawa N. (2021). Relugolix, an oral gonadotropin-releasing hormone receptor antagonist, reduces endometriosis-associated pain in a dose-response manner: a randomized, double-blind, placebo-controlled study. Fertil Steril. (Among 281 women with heavy menstrual bleeding with uterine leiomyomas were treated with relugolix [40 mg daily] or leuprorelin [injections of 1.88 or 3.75 mg monthly], response rates were similar in the two groups [82% vs 83%] but with a more rapid onset of action with relugolix; adverse event rates were similar in the two groups with ALT elevations above 5 times ULN in 2.2% vs 1.4% and there were no episodes with symptoms or jaundice and no hepatic serious adverse events).
Wallach JD, Deng Y, McCoy RG, Dhruva SS, Herrin J, Berkowitz A, Polley EC, et al. (2021). Real-world cardiovascular outcomes associated with degarelix vs leuprolide for prostate cancer treatment. JAMA Netw Open. (Among 2226 men with advanced prostate cancer who initiated degarelix or leuprolide therapy between 2007 and 2019 who were propensity-matched for risk factors, major adverse cardiovascular event [MACE] rates were similar in the two groups [10.2 vs 8.6 per 100-patient years], although degarelix was associated with a high rate of death from any cause).
Lopes RD, Higano CS, Slovin SF, Nelson AJ, Bigelow R, Sørensen PS, Melloni C, et al., PRONOUNCE Study Investigators. (2021). Cardiovascular safety of degarelix versus leuprolide in patients with prostate cancer: the primary results of the PRONOUNCE randomized trial. Circulation. (Among 545 men with prostate cancer and concurrent atherosclerosis cardiovascular disease treated with degarelix or leuprolide for at least one year, major cardiovascular adverse events [MACE} arose in 5.5% vs 4.1% and rates of testosterone suppression, disease progression, discontinuations for adverse events and serious adverse event rates were similar in both groups).
(2021). Myfembree for fibroid-associated heavy menstrual bleeding. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of the combination of relugolix, estradiol and norethindrone for heavy menstrual bleeding associated with fibroids, mentions adverse events of headache, hot flushes and hypertension, hair thinning, mood disorders, arthralgia and serum aminotransferase elevations).
Syed YY. (2022). Relugolix/estradiol/norethisterone (norethindrone) acetate: a review in symptomatic uterine fibroids. Drugs. (Review of the chemical structure, mechanism of action, history of development, pharmacology, clinical efficacy, and safety of the fixed combination of relugolix, estradiol and norethindrone acetate [Myfembree] for heavy menstrual bleeding and pelvic pain in premenopausal women with fibroids, mentions adverse events of hot flushes, sweating, alopecia, loss of libido, hypertension, irritability, dyspepsia, and slight decline in bone mineral density; no mention of ALT elevations or hepatotoxicity).
Giudice LC, As-Sanie S, Arjona Ferreira JC, Becker CM, Abrao MS, Lessey BA, Brown E, et al. (2022). Once daily oral relugolix combination therapy versus placebo in patients with endometriosis-associated pain: two replicate phase 3, randomised, double-blind, studies (SPIRIT 1 and 2). Lancet. (Among 1261 women with endometriosis and dysmenorrhea or pelvic pain enrolled in two prospective clinical trials comparing the combination of relugolix [120 mg] with estradiol and norethindrone vs placebo once daily for 24 weeks vs relugolix alone for 12 weeks followed by [delayed] combination therapy for 12 weeks, improvement in pain was achieved in 75% in the combination treatment group vs 27-30% in the placebo groups, and there were no “clinically important” differences in “laboratory parameters, including liver function tests” between the treatment groups).

## OTHER REFERENCE LINKS

1 Recent References on Relugolix: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Relugolix+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Relugolix: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Relugolix)